# Duloxetine

## OVERVIEW

### Introduction

Duloxetine is a selective serotonin and norepinephrine reuptake inhibitor widely used as an antidepressant and for neuropathic pain. Duloxetine therapy can be associated with transient asymptomatic elevations in serum aminotransferase levels and has been linked to rare instances of clinically apparent acute liver injury.

### Background

Duloxetine is a selective serotonin and norepinephrine reuptake inhibitor (SNRI) that is used as an antidepressant and for neuropathic pain. By blocking the reuptake of serotonin and norepinephrine in CNS synaptic clefts, the brain levels of these neurotransmitters are increased, which is associated with an antidepressant effect. Duloxetine was approved for use in the United States in 2004 and is available in delayed release capsules of 20, 30 and 60 mg in multiple generic forms and under the brand name Cymbalta. Indications for duloxetine therapy include major depression, generalized anxiety disorders, fibromyalgia and neuropathic pain. The recommended dosage in adults is 40 to 60 mg daily, which can be raised to 120 mg daily based upon tolerance and clinical effects. Common side effects are drowsiness, dyspepsia, nausea, headache, increased sweating, increased appetite, weight gain, urinary retention and sexual dysfunction. Rare, but potentially severe adverse events include suicidal thoughts and behaviors, mania, postural hypotension, syncope and falls, serotonin syndrome, seizures, severe skin rash, hypersensitivity reactions, hyponatremia, and glaucoma.

### Hepatotoxicity

Liver test abnormalities with ALT elevations above 3 times the upper limit of normal have been reported to occur in ~1% of patients on duloxetine, but elevations were usually self-limited and did not require dose modification or discontinuation. Rare instances of acute, clinically apparent episodes of liver injury with marked liver enzyme elevations with or without jaundice have been reported in patients on duloxetine. The onset of injury is usually within 1 to 6 months and the pattern of serum enzyme elevations is usually hepatocellular, but mixed and cholestatic forms have also been described. Fatal cases have been described but their relatedness to duloxetine has been quesitoned. Autoimmune (autoantibodies) and immunoallergic features (rash, fever, eosinophilia) are uncommon.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which duloxetine causes liver injury is not known, but is likely due to a metabolic byproduct. Duloxetine is metabolized by the liver, mainly via the cytochrome P450 system (CYP1A2 and 2D6) and is susceptible to drug-drug interactions with agents that alter activity of those microsomal enzymes (such as cimetidine and rifampin).

### Outcome and Management

The serum aminotransferase elevations that occur on duloxetine therapy are usually self-limited and do not require dose modification or discontinuation of therapy. Rare instances of acute liver failure and chronic hepatitis have been attributed to duloxetine therapy. Persons with intolerance to duloxetine may have similar reactions to other SNRIs and SSRIs and careful monitoring is warranted if other such agents are used.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass, SNRIs/SSRIs: Citalopram, Escitalopram, Fluoxetine, Fluvoxamine, Levomilnacipran, Paroxetine, Sertraline, Venlafaxine, Vilazodone, Vortioxetine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Duloxetine – Cymbalta®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=duloxetine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Duloxetine | 116539-59-4 | C18-H19-N-O-S | Image of Duloxetine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 08 January 2018

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity published in 1999; duloxetine is not mentioned).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of antidepressants mentions that post-marketing evaluation identified 58 potential cases of duloxetine hepatotoxicity using arising 2 to 8 weeks after starting therapy).
O'Donnell JM, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 396-415. (Textbook of pharmacology and therapeutics).
Mourilhe P, Stokes PE. Risks and benefits of selective serotonin reuptake inhibitors in the treatment of depression. Drug Saf 1998; 18: 57-82. (Review of pharmacology, efficacy and safety of SSRIs before the availability of duloxetine; no mention of ALT elevations or hepatotoxicity). 9466088
Grohmann R, Rüther E, Engel RR, Hippius H. Assessment of adverse drug reactions in psychiatric inpatients with the AMSP drug safety program: methods and first results for tricyclic antidepressants and SSRI. Pharmacopsychiatry 1999; 32: 21-8. (Analysis of reporting of adverse events among inpatients in 29 German hospitals between 1993 to 1997; 896 severe adverse events among 48,564 patients [1.8%], both total and hepatic events were more common with tricyclics than SSRIs). 10071179
Carvajal García-Pando A, García del Pozo J, Sánchez AS, Velasco MA, Rueda de Castro AM, Lucena MI.Hepatotoxicity associated with the new antidepressants. J Clin Psychiatry 2002; 63: 135-7. (Analysis of cases of hepatotoxicity from antidepressants in Spanish Pharmacovigilance System from 1989-1999, identified 99 cases; among SSRIs, 26 due to fluoxetine, 14 paroxetine, 6 fluvoxamine, 5 sertraline, 3 venlafaxine and 2 citalopram; among tricyclics, 16 clomipramine 7 amitriptyline, 6 imipramine; among miscellaneous, 3 nefazodone and 1 trazodone; but all similar in rate ~1-3 per 100,000 patient-years of exposure, except for nefazodone=29/100,000; analysis pre-dated the availability of duloxetine). 11874214
Lucena M, Carvajal A, Andrade R, Velasco A. Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf 2003; 2: 249-62. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; SSRIs are less likely to cause injury than tricyclics and MAO inhibitors; range of presentations, typically self-limited and rapid recovery; no hallmarks of hypersensitivity; duloxetine not discussed). 12904104
Spigset O, Hägg S, Bate A. Hepatic injury and pancreatitis during treatment with serotonin reuptake inhibitors: data from the World Health Organization (WHO) database of adverse drug reactions. Int Clin Psychopharmacol 2003; 18:157-61. (Among 27,542 reports of hepatic injury in WHO database, 786 were attributed to SSRIs [3%], including citalopram 42, fluoxetine 222, fluvoxamine 54, paroxetine 191, sertraline 112, nefazodone 91 and venlafaxine 74; only nefazodone had an excess of hepatic reports in relationship to total reports; duloxetine was not discussed as it was first marketed in 2004). 12702895
Degner D, Grohmann R, Kropp S, Rüther E, Bender S, Engel RR, Schmidt LG. Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry 2004; 37 Suppl 1: S39-45. ( Analysis of adverse drug reactions reported from 1993-2000 in 35 psychiatric hospitals; 0.7% of SSRI recipients had a severe adverse event; hepatic in 0.05%). 15052513
Hanje AJ, Pell LJ, Votolato NA, Frankel WL, Kirkpatrick RB. Case report: fulminant hepatic failure involving duloxetine hydrochloride. Clin Gastroenterol Hepatol 2006; 4: 912-7. (56 year old woman with non-Hodgkin lymphoma developed jaundice 1 year after starting duloxetine and 6 weeks after dose increase and addition of mirtazapine [bilirubin 9.9 rising to 18.8 mg/dL, AST 2477 U/L, Alk P 307 U/L, INR 2.8], with subsequent worsening and death from liver failure). 16797245
Pinzani V, Peyriere H, Hillaire-Buys D, Pageaux GP, Blayac BP, Larrey D. Specific serotonin recapture inhibitor(SSRI) antidepressants: hepatoxicity assessment in a large cohort in France. J Hepatol 2006; 44: S256. (Abstract: Analysis of French Pharmacovigilance data on SSRIs found 63 cases of hepatotoxicity from paroxetine, 45 fluoxetine, 30 citalopram, 18 sertraline, and 2 fluvoxamine; no mention of duloxetine).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther 2007; 25: 1401-9. (Among 126 cases of drug induced liver injury seen in Spain between 1993-2000, 3 were attributed to paroxetine and 3 to fluoxetine with a relative risk of injury to rate of use in the population of 3.0 and 1.8, respectively). 17539979
DeSanty KP, Amabile CM. Antidepressant-induced liver injury. Ann Pharmacother 2007; 41: 1201-11. (Review of drug induced liver injury and reports of injury from MAO inhibitors, SSRIs, tricyclics and atypical agents; mentions one case report of hepatotoxicity due to duloxetine complicated by concurrent use of mirtazapine [Hanje 2006]). 17609231
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 6 were attributed to duloxetine, 3 to atomoxetine, 2 to fluoxetine, 2 to bupropion, and 1 to sertraline as single agents). 18955056
Wernicke J, Pangallo B, Wang F, Murray I, Henck JW, Knadler MP, D'Souza DN, et al. Hepatic effects of duloxetine-I: non-clinical and clinical trial data. Curr Drug Saf 2008; 3: 132-42. (In animal studies, duloxetine showed no evidence of hepatocyte or mitochondrial toxicity; in clinical trials ALT levels above 3 times ULN occurred in ~1% of treated subjects; jaundice and ALT elevations occurred in 7/23,000 [.03%] on duloxetine vs 2/6000 [.03%] on placebo). 18690991
Wernicke J, Acharya N, Strombom I, Gahimer JL, D'Souza DN, Dipietro N, Uetrecht JP. Hepatic Effects of Duloxetine-II: Spontaneous Reports and Epidemiology of Hepatic Events. Curr Drug Saf 2008; 3: 143-53. (Analysis of spontaneous reporting of hepatic adverse events between 2004 and 2005; 5 million persons received duloxetine for 1.5 million person-years of exposure; 406 hepatic events, 26 probable and 127 possible; 225 had enzyme elevations only, 37 severe hepatic injury, 9 hepatic failure and 12 deaths [but none from hepatic failure]; overall rate of hepatic events of .008%). 18690992
Strombom I, Wernicke JF, Seeger J, D'Souza DN, Acharya N. Hepatic Effects of Duloxetine-III: Analysis of Hepatic Events Using External Data Sources. Curr Drug Saf 2008; 3: 154-62. (Analysis of two safety databases for hepatic adverse event reports on antidepressants; nefazodone had the highest signal in regards to disproportionality and incidence rate ratio followed by duloxetine, imipramine and amitriptyline among the antidepressants). 18690993
McIntyre RS, Panjwani ZD, Nguyen HT, Woldeyohannes HO, Alsuwaidan M, Soczynska JK, Lourenco MT, et al. The hepatic safety profile of duloxetine: a review. Expert Opin Drug Metab Toxicol 2008; 4: 281-5. (FDA approved duloxetine in 2004 and then published a warning letter regarding hepatotoxicity in October 2005; ALT elevations above 3 times ULN occurred in 1% of duloxetine vs 0.3% placebo recipients; authors summarize single case report from Hanje and the analyses published by Wernicke [2008]). 18363543
Vuppalanchi R, Hayashi PH, Chalasani N, Fontana RJ, Bonkovsky H, Saxena R, Kleiner D, et al; Drug-Induced Liver Injury Network (DILIN). Duloxetine hepatotoxicity: a case-series from the drug-induced liver injury network. Aliment Pharmacol Ther 2010; 32: 1174-83. (Among ~600 patients with drug induced liver injury enrolled in a US database between 2006 and 2009 [Chalasani 2008], 7 cases [~1%] were attributed to duloxetine; 6 women and 1 man, ages 29-58 years, and latency of 2-9 weeks [bilirubin 2.3-16.7 mg/dL, ALT 245-10,000 U/L, Alk P 92-468 U/L], usually hepatocellular, often severe but no deaths, resolving with stopping in all but one patient who had chronic Alk P elevations after a bout of severe cholestatic hepatitis). 20815829
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 4 due to psychotropic agents [1 each for fluoxetine, venlafaxine, quetiapine, and nefazodone]; none were linked to duloxetine). 20949552
Park YM, Lee BH, Lee HJ, Kang SG. Cholestatic jaundice induced by duloxetine in a patient with major depressive disorder. Psychiatry Investig 2010; 7: 228-30. (22 year old man developed jaundice 3 months after starting duloxetine and mirtazepine [bilirubin 3.3 mg/dL, direct not given, ALT and Alk P normal], resolving within a few months of stopping). 20927314
Kang SG, Park YM, Lee HJ, Yoon B. Duloxetine-induced liver injury in patients with major depressive disorder. Psychiatry Investig 2011; 8: 269-71. (2 men and 1 woman, ages 22, 65 and 37 years, developed minor ALT elevations with minimal symptoms and no jaundice, 1 to 20 weeks after starting duloxetine, resolving upon stopping). 21994516
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N: Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr 2011; 53: 182-9. (Among 30 children with suspected drug induced liver injury, half [n=15] were due to antimicrobials [minocycline 4, INH 3, azithromycin 3] and the rest largely due to CNS agents and anticonvulsants; one case was attributed to amitriptyline, but no other antidepressant was listed). 21788760
Gimenez C, Guce G, Lingisetty C, Bernhardt L. Severe INR elevation related to duloxetine use: a case report. Psychosomatics 2011; 52: 583-5. (44 year old man on long term warfarin, simvastastin, amlodipine, gabapentin and insulin therapy had marked rise in INR within one week of starting duloxetine [INR 11.9, bilirubin normal, ALT 99], resolving within a few days of vitamin K and fresh frozen plasma therapy, likely due to drug interactions rather than hepatotoxicity). 22054632
Xue F, Strombom I, Turnbull B, Zhu S, Seeger JD. Duloxetine for depression and the incidence of hepatic events in adults. J Clin Psychopharmacol 2011; 31: 517-22. (Analysis of reports to a large health insurance claims database including 21,457 adults treated with duloxetine betwen 2004 and 2006 found the relative risk for severe hepatic injury to be no higher in duloxetine treated than in control groups). 21694615
Yuan W, Williams B. Acute hepatic failure involving duloxetine hydrochloride. J Neuropsychiatry Clin Neurosci 2012; 24: E48-9. (58 year old woman developed abdominal pain and confusion 4 months after an increase in chronic duloxetine dose from 60 to 90 mg daily [bilirubin 2.9, ALT 3270 U/L, Alk P 146 U/L, INR 1.8, creatinine 3.9 mg/dL], with rapid recovery on stopping; was also taking trazodone, acetaminophen and atorvastatin). 22772703
Spina E, Trifirò G, Caraci F. Clinically significant drug interactions with newer antidepressants. CNS Drugs 2012; 26: 39-67. (Review of drug-drug interactions of antidepressants; duloxetine has extensive hepatic metabolism largely via CYP 1A2 so that levels can be increased by 1A2 inhibitors [cimetidine] and decreased by inducers [smoking, rifampin]; duloxetine is also a moderate CYP 2D6 inhibitor and may raise levels of risperidone and lower those of the active metabolite of tamoxifen). 22171584
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study from Iceland, 96 cases of drug induced liver injury were identified over a 2 year period, one of which was attributed to an antidepressant [venlafaxine]). 23419359
Park SH, Ishino R. Liver injury associated with antidepressants. Curr Drug Saf 2013; 8: 207-23. (Review of antidepressant induced liver injury lists and discusses 12 published cases attributed to duloxetine). 23914755
Voican CS, Corruble E, Naveau S, Perlemuter G. Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry 2014; 171: 404-15. (Review of antidepressant induced liver injury mentions that duloxetine has been linked to cases of hepatocellular, mixed and cholestatic injury and its frequency is estimated to be 26.2 per 100,000 patient years [Wernicke 2008]). 24362450
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to duloxetine). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases [2%] were attributed to antidepressants, including 7 to duloxetine [Vuppalanchi 2010]). 25754159
Lin ND, Norman H, Regev A, Perahia DG, Li H, Chang CL, Dore DD. Hepatic outcomes among adults taking duloxetine: a retrospective cohort study in a US health care claims database. BMC Gastroenterol 2015; 15: 134. (Analysis of a US health care database of patients initiating duloxetine therapy between 2004 and 2010 identified no cases of acute liver failure, but 5 cases of clinically significant liver injury among 7632 person-years of duloxetine use [0.07%]). 26467777
Bunchorntavakul C, Reddy KR. Drug hepatotoxicity: newer agents. Clin Liver Dis 2017; 21: 115-34. (Review of newly approved agents that have been linked to liver injury, including duloxetine). 27842767
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol 2016; 19. pii: pyv126. (Monitoring of 184,234 inpatients in 80 psychiatric hospitals for liver injury during antidepressant treatment identified 149 cases including 3 among 8015 duloxetine treated subjects [0.04%], a rate similar to other SSRIs and SNRIs; no cases resulted in acute liver failure or death from liver disease). 26721950
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al.; DILI-IT Study Group. Antidepressant-induced acute liver injury: a case-control study in an Italian inpatient population. Drug Saf 2018; 41: 95-102. (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in an prospective study between 2010 and 2014, 17 had been exposed to antidepressants including one who received duloxetine for 2 years [bilirubin 1.1 mg/dL, ALT 696 U/L, Alk P 122 U/L]). 28770534

## OTHER REFERENCE LINKS

1. Recent References on Duloxetine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=duloxetine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Duloxetine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=duloxetine)